# Amide Local Anesthetics

## OVERVIEW

### Introduction

The amide local anesthetics including lidocaine, bupivacaine and ropivacaine are commonly used for pain control during minor surgery or invasive procedures such as biopsies, small excisions or dental work. These local anesthetics have not been linked to serum enzyme elevations, but when given as constant infusions or repeated injections have been occasionally mentioned as possible causes of clinically apparent liver injury.

### Background

Lidocaine (lye' do kane), bupivacaine (bue piv' a kane) and ropivacaine (roe piv' a kane) are commonly used local anesthetics that are chemically referred to as aminoethylamides or amide local anesthetics. Their mechanism of anesthetic action is believed to be based upon inhibition of voltage-gated sodium channels, which results in membrane stabilization and slowing of membrane depolarization and repolarization. Local anesthetics have been shown to be effective and are used widely in preventing or reducing pain from minor surgery, incisions, biopsies, dental and obstetrical procedures and pain from wounds. They are usually given as a single injection locally into a lesion or the area of incision, but can be given as infusions for hours or for several days by epidural or wound-based catheters. Local anesthetic infusions can also be used for postoperative pain management. They have excellent tolerance and safety. Local anesthetics have variable durations of action, and short acting versions are often given with epinephrine, which decreases the rate of absorption limiting systemic exposure and prolonging the duration of action. Lidocaine was approved for use as a local anesthetic in the 1948 originally under the commercial name Xylocaine, ropivacaine in 1990 (Naropin), and bupivacaine in 1990 (Marcaine). Other less commonly used amide anesthetics include articaine (Septocaine: 2000), mepivacaine (Carbocaine: 1960), and prilocaine (Citanest: 1965). A liposomal and longer acting preparation of bupivacaine was approved for use in controlling postsurgical pain in 2011 (Exparel). Side effects of the local anesthetics are usually dose related and occur mostly as a result of systemic administration or exposure. They include neurological symptoms such as drowsiness, tinnitus, dizziness and twitching as well as gastrointestinal effects such as nausea, vomiting and constipation. Cardiovascular depression can also occur and ventricular arrhythmias, especially with higher doses.

### Hepatotoxicity

In clinical trials with the amide local anesthetics, serum aminotransferase and alkaline phosphatase elevations were rarely reported and were generally no more common than with placebo or comparator injections. Despite widespread use for many decades, the local amide anesthetics, when given as single or limited injections or infusions, have not been convincingly linked to instances of clinically apparent liver injury, and liver toxicity is not mentioned in product labels. Nevertheless, there have been several case series of jaundice arising a few days to as long as a month after use of bupivacaine given over several days as a constant infusion or as repeated injections into a localized area of pain. Some reports mentioned concurrent administration of an antibiotic such as cefazolin during the perioperative period, which might have accounted for the liver injury. However, in other reports, only bupivacaine was given. The liver injury was mixed or cholestatic and mild-to-moderate in severity, resolving within 1 to 2 months of onset without residual evidence of liver injury. In many instances, there was an accompanying low grade fever, rash or eosinophilia, suggesting a hypersensitivity reaction.

Likelihood score (lidocaine, articaine, mepivacaine, prilocaine, ropivacaine): E (unlikely causes of clinically apparent liver injury).

Likelihood score (bupivacaine): C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which bupivacaine might cause liver injury is unknown, but is most likely due to an idiosyncratic hypersensitivity reaction. The amide local anesthetics are metabolized locally and do not affect the activity of cytochrome P450 enzymes.

### Management

The liver injury linked to exposures to amide anesthetics has largely been limited to use of bupivacaine given by infusion or multiple injections over a period of 1 to 3 days. The injury was invariably self-limited, and no instance of chronic liver injury, vanishing bile duct syndrome or acute liver failure has been linked to bupivacaine or other local anesthetics. There have been no reports of recurrence after reexposure to bupivacaine, but in several instances patients with jaundice from bupivacaine infusions have later tolerated injections or infusions with lidocaine.

Drug Class: Anesthetics, Local

## CASE REPORT

### Case 1. Immunoallergic hepatitis arising 3 weeks after a 2 day course of bupivacaine infusions for postoperative pain control.

[Modified from Case 2 of: Chintamaneni P, Stevenson HL, Malik SM. Bupivacaine drug-induced liver injury: a case series and brief review of the literature. J Clin Anesth 2016; 32: 137-41. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/27290962)]

A 51 year old man developed fever, dark urine, pruritus and jaundice 3 weeks after an inguinal herniorrhaphy, during which he received bupivacaine injections followed by constant infusions into the area of the incision for two days postoperatively. He also received a single dose of cefazolin at the time of surgery and had taken simvastatin for hyperlipidemia for several years. He recovered from the surgery without complications until several weeks later when symptoms of fever and jaundice arose. He had no previous history of liver disease or risk factors for viral hepatitis. He drank an average of 10 beers weekly. On presentation, he was jaundiced but had no stigmata of chronic liver disease. Laboratory results showed elevations in liver tests, and serum bilirubin subsequently peaked at 9.5 mg/dL, ALT 491 U/L, AST 262 U/L and alkaline phosphatase 378 U/L, yielding an R ratio of ~4.3. The eosinophil count was 9%. He tested negative for markers of acute hepatitis A, B and C and for herpes simplex and Epstein-Barr virus infection. Autoantibodies were not detected. Imaging of the liver by ultrasound and CT showed no evidence of biliary obstruction or hepatic abnormalities. A liver biopsy showed a “mixed” cholestatic and hepatocellular pattern and occasional eosinophils. He recovered rapidly and all liver tests were normal 4 weeks later.

#### Key Points

Medication: | Bupivacaine
Pattern: | Mixed (R=4.3)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 3 weeks
Recovery: | Complete, 1 month after onset
Other medications: | Cefazolin, simvastatin

#### Comment

Bupivacaine when given by infusion over several days has been linked to at least 10 published cases of acute liver injury, generally arising 12 to 21 days after initiation of the local anesthetic. The clinical pattern of injury has been consistently marked by a mixed or cholestatic hepatitis with immunoallergic features (fever, rash, eosinophilia) and self-limited course, all liver tests returning to normal within 30 to 60 days of onset. The cases have been mild-to-moderate in severity. Strikingly, all instances have been described as a part of case series from a single institution. In the current case, the patient was also exposed to cefazolin, which has also been linked to a delayed cholestatic hepatitis. However, in other instances of liver injury after bupivacaine, no other drugs linked to liver injury were being taken. Other amide local anesthetics have not been implicated in this type of liver injury, but they are rarely given over a period of days and it is not clear whether the association with bupivacaine is specific or whether this type of reaction can occur with the other local anesthetics. In one case series, several patients were later treated with lidocaine for pain control without recurrence of the liver injury. Bupivacaine is similar in structure to the other amide anesthetics and is metabolized locally in many tissues. The cause of the hypersensitivity reaction with liver injury and jaundice remains unclear as does its frequency with different regimens of bupivacaine.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bupivacaine – Generic, Marcaine®, Exparel®

Lidocaine – Generic, Xylocaine®

Ropivacaine – Generic, Naropin®

DRUG CLASS

Anesthetics, Local

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Bupivacaine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lidocaine | 137-58-6 | C14-H22-N2-O | Image of Lidocaine Chemical Structure
Articaine | 23964-58-1 | C13-H20-N2-O3-S | Articaine Chemical Structure
Bupivacaine | 38396-39-3 | C18-H28-N2-O | Bupivacaine Chemical Structure
Mepivacaine | 96-88-8 | C15-H22-N2-O | Mepivacaine Chemical Structure
Prilocaine | 721-50-6 | C15-H22-N2-O | Prilocaine Chemical Structure
Ropivacaine | 84057-95-4 | C17-H26-N2-O | Ropivacaine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 05 July 2017

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999; does not discuss the local anesthetics).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Review of hepatotoxicity published in 2013; does not discuss local anesthetics).
Catterall WA, Mackie K. Local anesthetics. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 405-20. (Textbook of pharmacology and therapeutics).
Billström R, Blomberg HM. Cholestasis after interpleural bupivacaine for chronic upper limb pain. Anesth Analg 1993; 76: 1158-9. (Among 10 patients given repeated infusions of bupivacaine in intrapleural space for chronic arm pain, 3 women, ages 32-55 years, developed liver test abnormalities 2 days to 2 weeks later [bilirubin 0.6- 4.1 mg/dL, ALT 70-495 U/L, Alk P 330-1122 U/L], resolving within 1 month; none received antibiotics). 8484525
Uematsu H, Hiei K, Kawasaki H. [Unknown fever and abnormal liver functions after repeated epidural blocks with lidocaine for management of herpes zoster pain]. Masui 1994; 43: 405-8. Japanese. (A 67 year old woman received thoracic epidural nerve blocks with lidocaine for 2 weeks when she developed evidence of acute liver injury [described by Chinatmaneni 2016; no further information given]). 8182888
Ropivacaine--a new local anesthetic. Med Lett Drugs Ther 1997; 39 (1007): 80. (A concise review of the chemistry, pharmacology, clinical efficacy, adverse effects and costs of ropivacaine; does not mention hepatotoxicity or ALT elevations). 9269750
Yokoyama M, Ohashi I, Nakatsuka H, Mizobuchi S, Toda Y, Matsumi M, Morita K, Hirakawa M. Drug-induced liver disease during continuous epidural block with bupivacaine. Anesthesiology 2001; 95 (1): 259-61. (Three women and one man, ages 62-84 years, developed fever, rash and liver test abnormalities 10-18 days after starting bupivacaine as a continuous epidural infusion [peak bilirubin 1.0-9.6 mg/dL; ALT 99-976 U/L; Alk P 233-926 U/L, eosinophilia 9-12%], resolving within one month of stopping in all patients, and not recurring in 3 patients later given lidocaine). 11465567
Schurr MJ, Gordon DB, Pellino TA, Scanlon TA. Continuous local anesthetic infusion for pain management after outpatient inguinal herniorrhaphy. Surgery 2004; 136: 761-9. (Among 72 patients undergoing outpatient inguinal herniorrhaphy who received bupivacaine or placebo infusions, pain was less with the bupivacaine and side effects were minimal; no mention of ALT elevations or jaundice). 15467660
LeBlanc KA, Bellanger D, Rhynes VK, Hausmann M. Evaluation of continuous infusion of 0.5% bupivacaine by elastomeric pump for postoperative pain management after open inguinal hernia repair. J Am Coll Surg 2005; 200: 198-202. (Among 44 patients undergoing hernia repair who received bupivacaine or placebo infusions, there was less pain and opiate use with therapy compared to placebo and no reports of complications). 15664094
Chahar P, Cummings KC 3rd. Liposomal bupivacaine: a review of a new bupivacaine formulation. J Pain Res 2012; 5: 257-64. (A liposomal preparation of bupivacaine [depo-foam] allows for a slow and prolonged release of the anesthetic from the local site of infusion and is effective in controlling postsurgical pain, but its superiority to regular bupivacaine and its safety in the general practice situation remain unclear; no mention of hepatotoxicity). 23049275
Bupivacaine liposomal injection (Exparel) for post surgical pain. Med Lett Drugs Ther 2012; 54 (1387): 26-7. (Concise review of the pharmacology, clinical efficacy, safety and costs of bupivacaine liposomal injections shortly after its approval for use in postsurgical pain in the US; no mention of hepatotoxicity). 22469650
Dickerson DM, Apfelbaum JL. Local anesthetic systemic toxicity. Aesthet Surg J 2014; 34: 1111-9. (Review of systemic toxicities of locally administered anesthetics which are marked early by dizziness, drowsiness, confusion and tinnitus, and which can be followed by central nervous system and cardiac abnormalities including seizures, coma, agitation, bradycardia, tachycardia, hypotension, EKG abnormalities and ventricular arrhythmias which can be severe and even fatal; no mention of hepatotoxicity). 25028740
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to local anesthetics). 25754159
Chintamaneni P, Stevenson HL, Malik SM. Bupivacaine drug-induced liver injury: a case series and brief review of the literature. J Clin Anesth 2016; 32: 137-41. (Three men, ages 51-66 years, developed fever, pruritus and jaundice 14-21 days after inguinal hernia repair under general anesthesia and with intra- and post-operative infusions of 98-171 mg of bupivacaine over 1-2 days [peak bilirubin 5.5-11.1 mg/dL, ALT 237-491 U/L, Alk P 365-585 U/L, eosinophils 7-9%], resolving within 1 month of onset; 2 had received single doses of cefazolin and 1 ciprofloxacin: Case 1). 27290962

## OTHER REFERENCE LINKS

1. Recent References on Lidocaine, Bupivacaine, Ropivacaine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Lidocaine+Bupivacaine+Ropivacaine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lidocaine, Bupivacaine, Ropivacaine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lidocaine+Bupivacaine+Ropivacaine)